# Tepotinib

## OVERVIEW

### Introduction

Tepotinib is an orally available, small molecule inhibitor of the mesenchymal-epithelial transition (MET) factor tyrosine kinase receptor that is used to treat selected cases of non-small cell lung cancer (NSCLC). Serum aminotransferase elevations are common during therapy with tepotinib, but it has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Tepotinib (tep oh’ ti nib) is an orally available, small molecule inhibitor of the mesenchymal-epithelial transition (MET) factor tyrosine kinase receptor that blocks the binding of its ligand, hepatocyte growth factor (HGF), which normally activates signaling pathways involved in cell proliferation, motility, and invasion. The MET gene is mutated or overexpressed in several human cancers including lung, liver, breast and ovarian. Tepotinib has special activity against the mutated variant of the MET receptor produced by exon 14 skipping which is found in 3% to 4% of refractory NSCLC. Tepotinib was found to inhibit cancer cell growth in several tissue culture and animal models of MET dysregulated cancers. In a moderately sized (n=255), open label trial, tepotinib was found to induce objective responses in 43% of patients with metastatic non-small cell lung cancer harboring MET mutations regardless of previous treatment status. Tepotinib was approved in the United States in 2021 for adults with unresectable or advanced NSCLC with documented mutations that cause MET exon 14 skipping, the second such tyrosine kinase inhibitor approved for this indication (the first being capmatinib). Tepotinib is available in tablets of 225 mg under the brand name Tepmetko. The recommended dose is 450 mg orally once daily until disease progression or unacceptable toxicity. Side effects are common and arise in almost all patients treated with tepotinib. Severe adverse reactions occur in up to 45% of patients and lead to dose interruptions in 44%, dose adjustments in 30%, and permanent discontinuations in 20%. Common side effects include edema, nausea and vomiting, abdominal pain, diarrhea or constipation, anorexia, musculoskeletal pain, fatigue, fever, cough, dyspnea, and rash. Uncommon but potentially severe adverse events include pneumonitis, interstitial lung disease, hepatotoxicity, photosensitivity, hypersensitivity reactions, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of tepotinib in patients with solid tumors harboring MET mutations, liver test abnormalities were frequent although usually self-limited and mild. Some degree of ALT elevations arose in 44% of tepotinib treated patients and were above 5 times the upper limit of normal (ULN) in 4%. In these trials that enrolled 255 patients, dose interruptions due to ALT or AST elevations occurred in 3%, but permanent discontinuations in less than 1%. The liver test abnormalities had a median onset of 30 days after initiation of therapy. While serum aminotransferase elevations were occasionally quite high (5 to 20 times upper limit of normal), there were no accompanying elevations in serum bilirubin and no patient developed clinically apparent liver injury with jaundice. The product label for tepotinib recommends monitoring for routine liver tests before, at 2 week intervals during the first 3 months of therapy, and monthly thereafter as clinically indicated.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from tepotinib is unknown, but the pattern of abnormalities suggests direct liver injury. Tepotinib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4 and 2C8, and is susceptible to drug-drug interactions with agents that inhibit or induce these CYPs. Tepotinib is also an inhibitor of P-glycoprotein (P-gp) and concurrent use of a P-gp substrate may lead to serious toxicities. Because of known additive toxicity, concomitant use of drugs that are known P-gp substrates should be avoided or the dose of tepotinib adjusted accordingly.

### Outcome and Management

The product label for tepotinib recommends monitoring for routine liver tests before starting treatment, at 2 week intervals during the first 3 months of treatment and monthly thereafter as clinically indicated. Serum aminotransferase elevations above 5 times the upper limit of normal should lead to dose reduction or temporary cessation of tepotinib therapy and careful monitoring. Restarting therapy in a reduced dose can be done with caution and continued monitoring. In patients with jaundice or symptoms of liver injury accompanying the serum aminotransferase elevations, tepotinib should be promptly discontinued and not restarted. Cross sensitivity to liver injury is uncommon among the antineoplastic, small molecule enzyme and tyrosine receptor inhibitors, but currently there is no information on shared adverse event sensitivity of tepotinib with other antineoplastic kinase inhibitors including capmatinib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Related Drugs: Capmatinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tepotinib – Tepmetko®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tepotinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tepotinib | 1100598-32-0 | C29-H28-N6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 08 September 2023

Abbreviations: MET, mesenchymal epithelial transition receptor kinase gene; NSCLC, non-small cell lung cancer.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss tepotinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. 2020. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2021/214096Orig1s000MultidisciplineR.pdf (FDA website with initial multidiscipline clinical review of the safety and efficacy of tepotinib; states that the overall objective response rate was 43% in both treatment naïve and treatment refractory patients, and that adverse events arose in most patients and while 44% of patients had an ALT elevations, only 4% were above 5 times ULN, ALT elevations led to dose interruption in 7%, dose adjustment in 2%, but early discontinuation in none, one treated patient died of acute liver failure with ALT above 20 times ULN, but the event was considered unrelated to therapy; the reviewers concluded that “safety issues considered significant enough to warrant inclusion in the Warnings and Precautions section of the [product label] were interstitial lung disease/pneumonitis and hepatotoxicity”).
Awad MM, Oxnard GR, Jackman DM, Savukoski DO, Hall D, Shivdasani P, Heng JC, et al. MET exon 14 mutations in non-small-cell lung cancer are associated with advanced age and stage-dependent MET genomic amplification and c-Met overexpression. J Clin Oncol. 2016;34:721-30. (Among 6376 cancers undergoing genome sequencing, MET exon 14 mutations were found in 28 of 933 [3%] NSCLC, KRAS mutations in 34%, EGFR in 19%, ALK 4% and BRAF in 4%; those with the MET exon 14 skipping mutations tended to be older than those with KRAS or EGFR mutations). 26729443
Markham A. Tepotinib: first approval. Drugs. 2020;80:829-833. (Summary of the mechanism of action, history of development, pharmacodynamics, clinical efficacy and safety of tepotinib shortly after its first approval in Japan, does not discuss or mention ALT elevations or hepatotoxicity). 32361823
Wu YL, Cheng Y, Zhou J, Lu S, Zhang Y, Zhao J, Kim DW, et al.; INSIGHT Investigators. Tepotinib plus gefitinib in patients with EGFR-mutant non-small-cell lung cancer with MET overexpression or MET amplification and acquired resistance to previous EGFR inhibitor (INSIGHT study): an open-label, phase 1b/2, multicentre, randomised trial. Lancet Respir Med. 2020;8:1132-1143. (Among 55 adults with advanced or metastatic NSCLC with MET overexpression or amplification mutations treated with tepotinib and gefitinib vs standard platinum-based chemotherapy, the objective response rates were 45% vs 33% and adverse events were frequent [98% vs 100%] and included ALT elevations in 29% vs 9%, but there were no serious hepatic adverse events or treatment related deaths). 32479794
Paik PK, Felip E, Veillon R, Sakai H, Cortot AB, Garassino MC, Mazieres J, et al. Tepotinib in non-small-cell lung cancer with MET exon 14 skipping mutations. N Engl J Med. 2020;383:931-943. (Among 152 adults with advanced NSCLC with confirmed MET exon 14 skip mutations treated with tepotinib, the objective response rate was 46% and median duration of response of 11 months, while adverse events occurred in 98% of patients including treatment related serious adverse events in 15%, dose reductions in 33%, and permanent discontinuations in 11%, with ALT elevations in 7% which were above 5 times ULN in 2%). 32469185
Ryoo BY, Cheng AL, Ren Z, Kim TY, Pan H, Rau KM, Choi HJ, et al. Randomised Phase 1b/2 trial of tepotinib vs sorafenib in Asian patients with advanced hepatocellular carcinoma with MET overexpression. Br J Cancer. 2021;125:200-208. (Among 90 Asian patients with advanced hepatocellular carcinoma with MET overexpression treated with tepotinib [300, 500 or 1000 mg once daily] or sorafenib [400 mg twice daily], time to progression was slightly longer with tepotinib [2.9 vs 1.4 months], while adverse events rates were lower [82% vs 98% overall] with ALT elevations in 9% vs 16% [none greater than 5 times ULN]). 33972742
Mathieu LN, Larkins E, Akinboro O, Roy P, Amatya AK, Fiero MH, Mishra-Kalyani PS, et al. FDA approval summary: capmatinib and tepotinib for the treatment of metastatic NSCLC harboring MET Exon 14 Skipping Mutations or Alterations. Clin Cancer Res. 2022;28:249-254. (Summary of the data supporting the FDA accelerated approvals of capmatinib and tepotinib for metastatic NSCLC with MET exon 14 skipping mutations or alterations, mentions that the safety profiles were similar for the two agents, both of which had evidence of hepatotoxicity considered serious enough to include in Warnings and Precautions sections of the product labels). 34344795
Tseng LW, Chang JW, Wu CE. Safety of tepotinib challenge after capmatinib-induced pneumonitis in a patient with non-small cell lung cancer harboring MET exon 14 skipping mutation: a case report. Int J Mol Sci. 2022;23:11809. (69 year old Taiwanese man with metastatic NSCLC harboring MET exon14 skipping mutation developed an interstitial pneumonitis within a month of starting capmatinib that resolved with stopping and methyl prednisolone therapy, yet later tolerated tepotinib therapy without recurrence for one month when it was stopped because of disease progression). 36233109
Veillon R, Sakai H, Le X, Felip E, Cortot AB, Smit EF, Park K, et al. Safety of Tepotinib in Patients With MET Exon 14 Skipping NSCLC and Recommendations for Management. Clin Lung Cancer. 2022;23:320-332. (In a secondary analysis of common adverse events from an open label trial of tepotinib in 255 adults with MET exon 14 skipping NSCLC [Paik 2020], 31 patients developed treatment related ALT or AST elevations [12%], six [4%] being 5- to 20-fold elevated, and two [1.5%] greater than 20-fold elevated with median onset at 6 weeks and resolution after 5 weeks; patients were largely asymptomatic, none had jaundice, none required drug discontinuation, nine had temporary interruption, and two dose reduction). 35466070
Mazieres J, Paik PK, Garassino MC, Le X, Sakai H, Veillon R, Smit EF, et al. Tepotinib treatment in patients with MET exon 14-skipping non-small cell lung cancer: long-term follow-up of the VISION phase 2 nonrandomized clinical trial. JAMA Oncol. 2023;9:1260-1266. (Among 313 patients with advanced or metastatic NSCLC with MET exon 14 skipping mutations treated with tepotinib in two cohorts, the objective response rates was 51% and adverse events occurred in 99% leading to dose reductions in 36% and discontinuations in 25%, and including ALT elevations in 14% which were above 5 times ULN in 2.2%). 37270698
Liam CK, Ahmad AR, Hsia TC, Zhou J, Kim DW, Soo RA, Cheng Y, et al. Randomized trial of tepotinib plus gefitinib versus chemotherapy in EGFR-mutant NSCLC with EGFR inhibitor resistance due to MET amplification: INSIGHT final analysis. Clin Cancer Res. 2023;29:1879-1886. (Among 55 patients with advanced or metastatic NSCLC with MET overexpression treated with tepotinib and gefitinib vs standard platinum-based chemotherapy [Wu 2020], final analysis after 57.5 months of follow up showed similar progression free survival [4.9 vs 4.4 months] and adverse event rates; among those receiving tepotinib and gefitinib, ALT elevations arose in 32% and were above 5 times ULN in 3%). 36971777

## OTHER REFERENCE LINKS

Recent References on Tepotinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tepotinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Tepotinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tepotinib)